# Warfarin

## OVERVIEW

### Introduction

Warfarin is a commonly used oral anticoagulant with anti-vitamin K activity. Warfarin therapy is associated with rare instances of idiosyncratic, clinically apparent liver injury that are usually mild and rapidly reversible on stopping.

### Background

Warfarin (war' far in) was discovered after identification of the hemorrhagic activity that caused toxicity and bleeding in cattle after eating spoiled, sweet clover silage. Once the active component was shown to be bis-hydroxycoumarin, synthetic derivatives were developed and found to be effective rodenticides. Only thereafter were coumarin derivatives shown to be useful as anticoagulants in humans, and only with careful monitoring. Importantly, coumarin itself does not have anticoagulant activity but is used as an antineoplastic agent, and has different effects and side effects than its derivatives. Coumarin derivatives include warfarin, dicumarol, phenprocoumon and acenocoumarol. These compounds act by blocking the enzymatic reduction of vitamin K to its active form, which is responsible for the final steps of synthesis of several clotting factors (Factors II, VII, IX and X). The coumarin derivatives cause a prolongation of the prothrombin time which is beneficial in preventing progression or recurrence of deep vein thrombosis and pulmonary embolism. Oral anticoagulation is also used to prevent arterial or venous embolization after acute myocardial infarction, atrial fibrillation and prosthetic heart value placement. Warfarin was approved for use in the United States in 1961 and remains in wide use with more than 30 million prescriptions filled yearly. The typical dose is 5 mg daily for 2 to 4 days followed by 2 to 10 mg daily, based upon measurements of prothrombin time aiming at an international normalized ratio (INR) value of 2 to 3. Monitoring of the INR is essential during warfarin therapy, because bleeding is a common side effect and can be life-threatening and fatal. Side effects not directly attributable to the anticoagulant activity of warfarin are not common, but can include nausea, abdominal discomfort, diarrhea, anorexia, fever, alopecia, skin necrosis and bluish discoloration. Finally, warfarin is very sensitive to drug-drug interactions involving its metabolism or function and great care must be given to starting or stopping concurrent medications in patients on warfarin therapy. Severe bleeding episodes can be caused by administration of another medication that prolongs its half-life or activity. The availability of oral, non-vitamin K based anticoagulants that provide similar protection against thrombosis but have fewer adverse side effects and do not require regular monitoring of INR has decreased the use of warfarin, particularly in the elderly who are most prone to bleeding complications.

### Hepatotoxicity

Liver injury due to warfarin therapy is rare, but clinically apparent acute liver injury attributable to it has been reported. Liver injury is more common with other coumarin derivatives such as phenprocoumon and acenocoumarol, which are available in other countries but not in the United States. The typical case of acute liver injury arises within 3 to 8 weeks of starting warfarin, although rare instances of liver injury arising after months or years of therapy have been reported (and these long latencies are common with phenprocoumon hepatotoxicity). The pattern of liver enzyme elevations is typically cholestatic, but hepatocellular and mixed patterns have also been reported. Eosinophilia can occur, but other immunoallergic manifestations are not common nor are autoantibodies. Recovery can be prolonged, particularly with cholestatic injury. Recurrence upon reexposure has been described and can be more severe and result in death.

Overdose with warfarin can result in excessive bleeding and hepatic failure. In addition, chronic warfarin therapy has been associated with spontaneous bleeding including hepatic rupture and life-threatening intraperitoneal bleeding, even without trauma and with INR in the appropriate range.

Coumarin (as opposed to coumarin derivatives) is a benzopyrone, which is found in many plants and has a sweet, vanilla-like flavor. Coumarin itself does not have anticoagulant activity, which is only found in its derivatives. Coumarin inhibits macrophage function and has been used as an antineoplastic agent and to treat protein rich lymphedema, such as occurs in the arm after breast cancer therapy. Coumarin has been implicated in several cases of idiosyncratic, clinically apparent liver injury which is estimated to occur in 2 per 1000 patient years of use. Coumarin is not commercially available in the United States.

Likelihood score: C (probable rare cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of liver injury during oral anticoagulant therapy is unknown but it is clearly idiosyncratic with many instances of more rapid recurrence of more severe injury with reexposure, suggesting an immunologic basis.

### Outcome and Management

Most cases of liver injury due to warfarin are mild-to-moderate in severity and are self-limited, resolving once therapy is stopped. Recurrence of liver injury usually occurs with rechallenge, which should be avoided. There appears to be cross sensitivity to hepatic injury between warfarin and phenprocoumon, but not with acenocoumarol for uncertain reasons. However, these other coumarin derivatives are not available in the United States.

Drug Class: Antithrombotic Agents, Anticoagulants

Other Drugs in the Subclass, Anticoagulants: Dabigatran, Desirudin, Apixaban, Fondaparinux, Rivaroxaban, Heparins

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Warfarin – Generic, Coumadin®

DRUG CLASS

Antithrombotic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=warfarin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Warfarin | 81-81-2 | C19-H16-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 25 October 2020

Zimmerman HJ. Heparin. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-412. (Textbook of hepatotoxicity published in 1999; mentions that warfarin rarely produces hepatic injury, which when present is usually cholestatic, mild and presumably immunologically mediated).
Bhardwaj SS, Chalasani NP. Anticoagulants. Cardiovascular and antidiabetic medications. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 608-11. (Review of hepatotoxicity of coumarin derived anticoagulants published in 2007; the typical injury from warfarin is cholestatic often with an allergic-type hypersensitivity reaction arising as long as five years after starting).
Hogg K, Weitz JI. Blood coagulation and anticoagulant, fibrinolytic, and antiplatelet drugs. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 849-76. (Textbook of pharmacology and therapeutics).
Kreiter H, Fink U. (1967). Med Klin. (56 year old man developed anoxia, malaise and weight loss 5 years after starting acenocoumarol, with mild liver tests abnormalities which recurred 6 weeks after starting phenprocoumon [bilirubin 0.45 rising to 1.3 mg/dL, ALT 5 to 34 WE, Alk P 64 to 160 WE, 10% eosinophils], resolving within weeks of stopping).
Mogilner BM, Freeman JS, Blashar Y, Pincus FE. (1974). Reye's syndrome in three Israeli children. Possible relationship to warfarin toxicity. Isr J Med Sci. (Description of 3 children presenting with Reye syndrome-like symptoms with fatal outcome; one after a warfarin [rat poison] overdose, one having warfarin detected in urine after eating grass, and one with history of respiratory infection; all had microvesicular fat on autopsy).
Roberts MH, Johnston FR. (1975). Hepatic rupture from anticoagulant therapy. Arch Surg. (69 year old woman taking warfarin for 6 years had sudden hepatic rupture [protime 21.5 sec] requiring surgery and ultimately recovering).
den Boer W, Loeliger EA. (1976). Phenprocoumon-induced jaundice. Lancet. (43 year old woman who tolerated acenocoumarol developed jaundice 6 months after switching to phenprocoumon [bilirubin 42 mg/dL], resolving with prednisone therapy and recurring 3 weeks after restarting [bilirubin 30 mg/dL, ALT 540 U/L, Alk P 206 U/L], and resolving again upon stopping).
Rehnqvist N. (1978). Intrahepatic jaundice due to warfarin therapy. Acta Med Scand. (2 cases: 56 year old man developed ALT elevations within 8 days of starting warfarin and heparin, remaining elevated for 30 days until warfarin stopped; 57 year old man took overdose of warfarin [50 mg] in suicide attempt and developed jaundice [bilirubin not given; ALT and Alk P 3-4 times ULN] which lasted even when anticoagulant was changed to bishydroxycoumarin, resolving only when it was stopped).
Dizadji H, Hammer R, Strzyz B, Weisenberger J. (1979). Spontaneous rupture of the liver. A complication of oral anticoagulant therapy. Arch Surg. (73 year old woman on warfarin [duration not mentioned] developed rupture of the liver [protime 21.3 seconds, no trauma] requiring right lobectomy with subsequent liver failure and death 15 days later).
Jones DB, Makepeace MC, Smith PM. (1980). Jaundice following warfarin therapy. Postgrad Med J. (59 year old man developed jaundice and pruritus 6 months after starting warfarin [bilirubin 11.1 rising to 48 mg/dL, AST 50 U/L, Alk P 190 rising to 820 U/L], resolving 15 weeks after stopping).
Slagboom G, Loeliger EA. (1980). Coumarin-associated hepatitis. Report of two cases. Arch Intern Med. (Two patients of unstated gender and age developed jaundice 6 months and many years after starting phenprocoumon [bilirubin 9.6 and 2.3 mg/dL, ALT 116 and 41 U/L, Alk P 100 and 112 U/L], resolving upon stopping and recurring 3 and 11 weeks after restarting, and treated with prednisone).
Adler E, Benjamin SB, Zimmerman HJ. (1986). Cholestatic hepatic injury related to warfarin exposure. Arch Intern Med. (70 year old man developed jaundice 10 days after starting warfarin [bilirubin 11.4 rising to 47 mg/dL, AST 69 U/L, Alk P 588 U/L], resolving slowly upon stopping; history revealed similar cholestatic episode with eosinophilia arising 2 weeks after starting warfarin several years in the past).
Herrmann KS, Kreuzer H. (1988). Klin Wochenschr. (28 year old man developed serum enzyme elevations shortly after starting phenprocoumon [bilirubin not given, ALT 420 U/L, GGT 96 U/L], which improved on stopping and recurred on restarting; subsequently switched to acenocoumarol which he tolerated without liver abnormalities, but developed agranulocytosis without liver enzyme elevations).
Cox D, O'Kennedy R, Thornes RD. (1989). The rarity of liver toxicity in patients treated with coumarin (1, 2-benzopyrone). Hum Toxicol. (Coumarin is without anticoagulant activity, but is antineoplastic; among 2173 patients treated with coumarin, 17 [0.8%] developed hepatotoxicity, but only 8 were considered due to coumarin with onset 1-6 months after starting, jaundice in 1 [bilirubin 13.3 mg/dL] with enzyme elevations [ALT 115-960 U/L, Alk P usually normal], resolving with stopping but recurring with re-exposure in 6 patients).
de Man RA, Wilson JH, Schalm SW, ten Kate FJ, van Leer E. (1990). Phenprocoumon-induced hepatitis mimicking non-A, non-B hepatitis. J Hepatol. (58 year old man developed jaundice 7 months after starting phenprocoumon, which improved upon stopping but recurred within 4 weeks of restarting [bilirubin 8.1 mg/dL, ALT 589 U/L, Alk P 208 U/L, 5% eosinophils], which resolved within 3 months of switching to heparin; the initial episode had been mistakenly attributed to non-A, non-B hepatitis).
Erichsen C, Søndenaa K, Söreide JA, Andersen E, Tysvoer A, Sndenaa K, Sreide JA. (1993). Spontaneous liver hematomas induced by anti-coagulation therapy. A case report and review of the literature. Hepatogastroenterology. (55 year old woman on warfarin therapy developed several intrahepatic hematomas 4 days after starting trimethoprim-sulfamethoxazole for bronchitis, perhaps caused by drug-drug interactions and intrahepatic bleeding).
de Man RA. (1993). Phenprocoumon-induced liver failure. Neth J Med. (52 year old woman developed jaundice 6 months after starting phenprocoumon with prolonged course, later tolerating acenocoumarol but redeveloping severe liver injury 3 weeks after restarting phenprocoumon [bilirubin 12.2 mg/dL, ALT 1865 U/L, Alk P 159 U/L], progressing to hepatic failure and death 4 weeks later).
Scott DA, Netchvolodoff CV, Bacon BR. (1991). Delayed subcapsular hematoma after percutaneous liver biopsy as a manifestation of warfarin toxicity. Am J Gastroenterol. (61 year old man on warfarin underwent liver biopsy after correction of protime, but had subcapsular bleed 5 days after restarting warfarin [2 days after biopsy]).
Matsukawa R, Uemura S, Fukuchi S, Tsuruta Y, Murakami S. (1994). Nippon Kyobu Geka Gakkai Zasshi.
Höhler T, Schnütgen M, Helmreich-Becker I, Mayet WJ, Mayer zum Büschenfelde KH. (1994). Drug-induced hepatitis: a rare complication of oral anticoagulants. J Hepatol. (56 year old woman developed jaundice 8 months after starting phenprocoumon [bilirubin 4.2 mg/dL, ALT 377 U/L, Alk P 190 U/L], improving when switched to heparin but recurring with restarting phenprocoumon as well as with warfarin [Alk P and GGT rising within 7 days]).
Beinssen AP. (1994). Possible coumarin hepatotoxicity. Med J Aust. (50 year old woman with lymphedema after breast cancer surgery developed jaundice 7 weeks after starting coumarin [bilirubin 10.2 mg/dL, ALT 1335 U/L], but was continued on therapy until 10 weeks and suffered a protracted course of liver injury).
Casley-Smith JR, Casley-Smith JR. (1995). Frequency of coumarin hepatotoxicity. Med J Aust. (Summary of hepatotoxicity from coumarin by members of the Lymphoedema Association of Australia; among 1106 patients in 7 clinical trials of coumarin for an average of 14.6 months, 2 developed jaundice, one of whom required liver transplantation; since licensure, 4 of an estimated 1750 exposed patients were reported with hepatotoxicity suggesting a rate of ~0.2%).
Ehrenforth S, Scharrer I, Herrmann G. (1995). Dtsch Med Wochenschr. (55 year old woman developed jaundice 6 months after starting phenprocoumon [bilirubin 4.2 mg/dL, ALT 377 U/L, Alk P 184 U/L], resolving once switched to acenocoumarol).
Woolley S, Burger HR, Zellweger U. (1995). Dtsch Med Wochenschr. (78 year old woman developed jaundice 10 weeks after starting phenprocoumon that ultimately resolved, but recurred 6 weeks after restarting [bilirubin 11.5 rising to 25.6 mg/dL, ALT 714 U/L, Alk P 424 U/L], resolving upon again stopping).
Hautekeete M, Holvoet J, Hubens H. (1995). Cytolytic hepatitis related to the oral anticoagulant phenprocoumon. Gastroenterol Clin Biol. (32 year old man developed jaundice 6 months after starting phenprocoumon [bilirubin 7.8 rising to 40.5, ALT 71 times ULN, Alk P 1.3 times ULN], resolving with stopping, but recurring within 5 weeks of restarting and resolving upon switching to low molecular weight heparin).
Ciorciaro C, Hartmann K, Stoller R, Kuhn M. (1996). Schweiz Med Wochenschr. (Analysis of all cases of hepatic injury reported to Swiss registry between 1981 and 1995, 11 [1.5%] of 674 cases were due to anticoagulants; 10 cases could be analyzed, 7 due to phenprocoumon and 3 to acenocoumarol; 4 with enzyme elevations only [latency 2-6 days], 6 with jaundice and hospitalization [latency 10 days to 6 years]).
Wuillemin WA, Zenhäern R, Bernhard MC, Läle B. (1997). Phenprocoumon-induced hepatitis delaying precise diagnosis in a thrombophilic patient with activated protein C resistance due to factor V R506Q mutation. Am J Med. (38 year old woman developed jaundice 4 months after starting phenprocoumon [bilirubin 30.8 mg/dL, ALT 3330 U/L, Alk P 272 U/L], resolving in 3 months, but recurring 5 years later when phenprocoumon was restarted for 5 weeks [bilirubin 7.5 mg/dL, ALT 1724 U/L, Alk P 200], resolving in 3-5 months).
Loprinzi CL, Sloan J, Kugler J. (1997). Coumarin-induced hepatotoxicity. J Clin Oncol. (Among 138 patients enrolled in a controlled trial of coumarin [5,6-benzo-a-pyrone, not an anticoagulant] for breast cancer, 6 developed hepatotoxicity [9% on active drug], 5 with asymptomatic AST elevations and one with clinically apparent liver injury and jaundice [bilirubin 19.5 mg/dL, AST 2315 U/L, Alk P 214 U/L], 2 months after starting and resolving within 3 months of stopping).
Ghosh P, Markin RS, Sorrell MF. (1997). Coumarin-induced hepatic necrosis. Am J Gastroenterol. (66 year old man developed jaundice 3 months after starting experimental therapy with coumarin for prostate cancer [bilirubin 4.6 mg/dL, ALT 1094 U/L], but it was continued until 15 weeks when he was deeply jaundiced [bilirubin 13.9 mg/dL, ALT 936 UL, Alk P 292 U/L], resolving within 9 weeks of stopping).
Koch S, Beurton I, Bresson-Hadni S, Monnot B, Hrusovsky S, Becker MC, Vanlemmens C, et al. (1997). Gastroenterol Clin Biol. (Two women, ages 40 and 45 years, developed jaundice and pruritus 5 months after starting coumarin for lymphedema [bilirubin 5.8 and 25.1 mg/dL, ALT 30 and 100 times ULN, Alk P normal], resolving within 2 months of stopping; one was restarted on coumarin and redeveloped jaundice within 3 weeks).
Kremer Hovinga JA, Wuillemin WA. (1999). Ther Umsch. (Same case as described in English by Wuillemin with other authors [1997]).
Ehrenforth S, Schenk JF, Scharrer I. (1999). Liver damage induced by coumarin anticoagulants. Semin Thromb Hemost. (Two cases: first is same as described by Höhler [1994] with further follow up: patient could not tolerate low molecular weight heparins and was treated with acenocoumarol without recurrence; second case was 46 year old woman who had mildly raised enzymes 7 months after starting phenprocoumon [ALT 86 U/L, Alk P 171 U/L], resolving within 2 months of switching to low molecular weight heparin).
Capoferri M, Realini S, Balestra B. (2000). Praxis. (76 year old woman was treated with acenocoumarol and then phenprocoumon, developing jaundice 8 months later and 2 months after starting verapamil [bilirubin 8.8 mg/dL, ALT 503 U/L, Alk P 276 U/L], resolving in 5 weeks and recurring 1 month after phenprocoumon [but not verapamil] was restarted [bilirubin 5.9 mg/dL, ALT 563 U/L, Alk P 248 U/L], resolving in 3 months and then tolerating acenocoumarol).
Bux-Gewehr I, Zotz RB, Scharf RE. (2000). Phenprocoumon-induced hepatitis in a patient with a combined hereditary hemostatic disorder. Thromb Haemost. (51 year old woman developed jaundice 3 weeks after starting a second course of phenprocoumon [bilirubin 3.0 mg/dL, ALT 801 U/L, Alk P 376 U/L], resolving upon stopping and not recurring when later treated with warfarin).
Hinrichsen H, Lüttges J, Klöppel G, Fölsch UR, Schmidt WE. (2001). Idiosyncratic drug allergic phenprocoumon-induced hepatitis with subacute liver failure initially misdiagnosed as autoimmune hepatitis. Scand J Gastroenterol. (46 year old woman developed jaundice 5 months after starting phenprocoumon [bilirubin 26.2 mg/dL, ALT 644 U/L, GGT 135 U/L, ANA 1:640], resolving over 4 months with prednisone therapy and recurrence of enzyme elevations 1 month after restarting [ALT 127 U/L] while still on prednisone).
Schneider AR, Hartmann D, Arnold JC, Bohrer MH, Riemann JF. (2001). Dtsch Med Wochenschr. (52 year old woman developed abdominal pain 7 months after starting phenprocoumon [bilirubin 1.7 mg/dL, ALT 657 U/L, GGT 117 U/L], which resolved upon stopping but recurred within 3 weeks of restarting [bilirubin 7.6 mg/dL, ALT 1170 U/L, GGT 152], resolving with prednisone therapy over next 4 months).
Weber T, Hinterreiter M, Knoflach P. (2001). Dtsch Med Wochenschr. (Patient developed jaundice 2 months after starting phenprocoumon and then related having similar episode 10 years before, 7 months after starting phenprocoumon; few details given).
Bamanikar A, Hiremath S. (2002). Hepatotoxic reaction to warfarin in a recovering hepatitis patient with hypoalbuminenia. J Assoc Physicians India. (65 year old man developed jaundice 2 years after starting warfarin [bilirubin 11.8 mg/dL, ALT 4765 U/L, Alk P 102 U/L], resolving slowly but with worsening of jaundice when warfarin was given).
Cordes A, Vogt W, Dahm HH, Maier KP. (2003). Dtsch Med Wochenschr. (61 year old woman developed jaundice 2 years after starting phenprocoumon [bilirubin 18.5 mg/dL, ALT 263 U/L, Alk P normal], with slow recovery 2-3 months after stopping).
Schimanski CC, Burg J, Möhler M, Höhler T, Kanzler S, Otto G, Galle PR, et al. (2004). Phenprocoumon-induced liver disease ranges from mild acute hepatitis to(sub-) acute liver failure. J Hepatol. (Between 1992 and 2002, 8 patients were seen with phenprocoumon hepatotoxicity, including 3 men and 5 women, ages 30 to 64 years, latency 3-64 months, 4 with jaundice, 2 cholestatic, 3 liver failure [1 died, 2 liver transplantation], 2 had recurrence when switched to warfarin).
Kapan M, Kapan S, Karabicak I, Bavunoglu I. (2005). Simultaneous rupture of the liver and spleen in a patient on warfarin therapy: report of a case. Surg Today. (32 year old man developed rupture of liver and spleen 2 weeks after starting warfarin [INR 1.65, hematocrit 23%], leading to splenectomy and segmental hepatic resection).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J. (2008). Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver injury in the US collected from 2004 to 2008, none were attributed to warfarin or other anticoagulants).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury, but none were attributed to warfarin).
Park IC, Baek YH, Han SY, Lee SW, Chung WT, Lee SW, Kang SH, et al. (2013). Simultaneous intrahepatic and subgaleal hemorrhage in antiphospholipid syndrome following anticoagulation therapy. World J Gastroenterol. (18 year old woman with antiphospholipid syndrome developed spontaneous intrahepatic hemorrhage after 6 years of warfarin therapy [INR 1.8, bilirubin and ALT not given, Alk P 214 U/L], recurring on restarting warfarin, but not when switched to clopidogrel and hydroxychloroquine).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none were attributed to warfarin).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to warfarin or other anticoagulants).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al. (2015). United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, no cases were attributed to warfarin, but single cases were linked to dabigatran and prasugrel).
Liakoni E, Rätz Bravo AE, Krähenbühl S. (2015). Hepatotoxicity of new oral anticoagulants (NOACs). Drug Saf. (Systematic review of evidence of hepatotoxicity of new oral anticoagulants including rivaroxaban, apixaban, edoxaban and dabigatran found 22 cases of liver injury due to rivaroxaban, 2 dabigatran, 2 apixaban, but none to edoxaban).
Li L, Li XG, Pei F, Xu J. (2015). Zhonghua Gan Zang Bing Za Zhi.
Alonso A, MacLehose RF, Chen LY, Bengtson LG, Chamberlain AM, Norby FL, Lutsey PL. (2017). Prospective study of oral anticoagulants and risk of liver injury in patients with atrial fibrillation. Heart. (Analysis of a database on more than 1 million patients with nonvalvular atrial fibrillation on anticoagulants identified 960 hospitalizations with liver injury, rates being highest for warfarin [9 per 1000 patient years], intermediate for rivaroxaban [6.6], and lowest for apixaban [5.6] and dabigatran [4.0]).
Casale M, Picariello S, Corvino F, Cerasari G, Scianguetta S, Rossi F, Persico M, Perrotta S. (2018). Life-threatening drug-induced liver injury in a patient with β-thalassemia major and severe iron overload on polypharmacy. Hemoglobin. (20 year old man with beta-thalassemia developed progressive weakness and jaundice 4 months after starting warfarin, carvedilol and both intravenous deferoxamine and oral deferiprone for atrial fibrillation, heart failure and iron overload [bilirubin ~11 mg/dL, ALT 146 U/L, Alk P not provided, GGT 57, INR ~16], improving slowly after stopping all medications and eventually tolerating reinstitution of deferiprone; the authors attributed the liver injury to warfarin).
Zhao J, Blais JE, Chui CSL, Suh IH, Chen EYH, Seto WK, Mok MT, et al. (2020). Association between nonvitamin K antagonist oral anticoagulants or warfarin and liver injury: a cohort study. Am J Gastroenterol. (Analysis of patients with newly diagnosed atrial fibrillation and initiation of anticoagulant therapy identified in an electronic health record database in Hong Kong over an 8 year period, identified 6849 patients treated with warfarin and a propensity matched cohort of 6849 patients treated with oral agents among who 373 [2.7%] subsequently developed evidence of liver injury, rates being higher with warfarin [3.4%] than with newer oral anticoagulants [2.1%]).
Björnsson HK, Gudmundsson DO, Björnsson ES. (2020). Liver injury caused by oral anticoagulants: A population-based retrospective cohort study. Liver Int. (Population based analysis of persons starting anticoagulants over a 10 year period based upon national Icelandic prescription and healthcare databases, identified 3 cases of drug induced liver injury, all in elderly women, all hepatocellular, 2 with jaundice, and all due to rivaroxaban [among 3446 persons exposed: 1:1,100], but none due to warfarin [9101 exposed], apixaban [1903], dabigatran [1335], or edoxaban [34]).

## OTHER REFERENCE LINKS

1 Recent References on Warfarin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(warfarin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Warfarin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=warfarin)